# Rotigotine

## OVERVIEW

### Introduction

Rotigotine is a non-ergot dopamine receptor agonist used in the therapy of Parkinson disease and restless leg syndrome. Administered as a once daily transdermal patch, rotigotine has not been associated with serum enzyme elevations during treatment or with episodes of clinically apparent liver injury.

### Background

Rotigotine (roe tig' oh teen) is a synthetic dopamine agonist that is used to treat Parkinson disease and restless leg syndrome. Rotigotine is a nonselective agonist of dopamine receptors with highest affinity for the D3 class of receptors. It is structurally unrelated to ergot derivatives. Rotigotine is formulated as a transdermal patch which allows for once daily application and provides longer lasting and sustained plasma levels in comparison to other, oral non-ergot dopamine receptor agonists, such as ropinirole and pramipexole which are usually administered several times daily. In multiple placebo controlled clinical trials, rotigotine improved motor and daily activity scores in patients with Parkinson disease and in restless leg syndrome. Rotigotine was approved for this use in the United States in 2007. Current indications include both Parkinson disease and restless leg syndrome. Rotigotine is available in transdermal formulations which deliver 1, 2, 3, 4, 6 or 8 mg per 24 hours under the brand name Neupro. Rotigotine is typically initiated in doses of 2 mg per 24 hours in Parkinson disease and 1 to 3 mg per 24 hours for restless leg syndrome, with dose adjustments based upon tolerance and effects. Common side effects of rotigotine include application site reactions (erythema, pruritus) and systemic symptoms of nausea, dizziness, headache and somnolence – symptoms that are typical of dopaminergic stimulation. Weight gain and peripheral edema have also been described. Rare, but potentially severe adverse reactions include sudden sleep onset, sleep attacks, hallucinations, hypotension and syncope.

### Hepatotoxicity

In multiple, controlled trials in Parkinson disease and restless leg syndrome, rotigotine transdermal patches were not associated with serum enzyme elevations, liver related severe adverse events or instances of clinically apparent liver injury. Since the approval and more wide scale use of rotigotine, there have been no published case reports of liver injury associated with its use and hepatotoxicity is not mentioned in the product label.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Liver Injury

Rotigotine is extensively metabolized in the liver acted upon by multiple cytochrome P450 isomers and conjugating enzymes. It has little or no effect on CYP isoenzyme activities and is not affected by drugs that inhibit or induce individual members of the microsomal enzyme system. The lack of hepatotoxicity of rotigotine may related to its transdermal formulation and relatively low daily dose (1 to 8 mg per 24 hours).

Drug Class: Antiparkinson Agents

Other Drugs in the Subclass, Dopamine Receptor Agonists: Apomorphine, Bromocriptine, Pergolide, Pramipexole, Ropinirole

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rotigotine – Neupro®

DRUG CLASS

Antiparkinson Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=rotigotine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Rotigotine | 99755-59-6 | C19-H25-N-O-S | Rotigotine Chemical Structure

## REFERENCES

References updated: 21 July 2017

Zimmerman HJ. Antiparkinsonism drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 715-7. (Expert review of hepatotoxicity published in 1999; among anticholinergic agents, "only trihexyphenidyl has been incriminated in hepatic injury"; other antiparkinsonism drugs discussed include levodopa, lergotrile [no longer available], pergolide and bromocriptine, but not ropinirole).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier Inc, 2013, pp. 443-62. (Review of hepatotoxicity of agents acting on the central nervous system).
Standaert DG, Roberson ED. Treatment of central nervous system degenerative disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 609-28. (Textbook of pharmacology and therapeutics).
Lambert D, Waters CH. Comparative tolerability of the newer generation antiparkinsonian agents. Drugs Aging 2000; 16: 55-65. (Review of mechanism of action, tolerability and safety of selegiline, pramipexole, ropinirole, tolcapone and entacapone in Parkinson disease). 10733264
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to agents used for Parkinson disease). 20949552
Giladi N, Boroojerdi B, Korczyn AD, Burn DJ, Clarke CE, Schapira AH; SP513 investigators. Rotigotine transdermal patch in early Parkinson's disease: a randomized, double-blind, controlled study versus placebo and ropinirole. Mov Disord 2007; 22: 2398-404. (Among 561 patients with early Parkinson disease treated with rotigotine, ropinirole or placebo for 24 weeks, rates of response were 52%, 68% and 30% and side effects that were more common with rotigotine than placebo were application site reactions [38% vs 7%], nausea [29% vs 16%], vomiting [12% vs 3%], dizziness [14% vs 10%], and sleep attacks [3% vs 0]; no mention of ALT elevations or liver related severe adverse events). 17935234
Transdermal rotigotine (Neupro) for Parkinson's disease. Med Lett Drugs Ther 2007; 49 (1268): 69-70. (Concise review of the mechanism of action, efficacy, safety and costs of transdermal rotigotine shortly after its approval in the US; mentions side effects of nausea, dizziness and somnolence, but not serum ALT elevations or hepatotoxicity). 17712291
LeWitt PA, Lyons KE, Pahwa R; SP 650 Study Group. Advanced Parkinson disease treated with rotigotine transdermal system: PREFER Study. Neurology 2007; 68: 1262-7. (Among 351 patients with advanced Parkinson disease treated with transdermal rotigotine [8 or 12 mg/234 hours] or placebo for 25 weeks, there were greater decreases in “off” time with rotigotine; side effects were those typical of dopaminergic stimulation, and “clinical laboratory test results…revealed no tendencies for the study medication to cause toxicity”). 17438216
Watts RL, Jankovic J, Waters C, Rajput A, Boroojerdi B, Rao J. Randomized, blind, controlled trial of transdermal rotigotine in early Parkinson disease. Neurology 2007; 68: 272-6. (Among 277 patients with early Parkinson disease treated with transdermal rotigotine or placebo for 6 months, those on rotigotine had more improvement in motor activity, but also were more likely to have nausea, vomiting, diarrhea, somnolence and insomnia; no mention of ALT elevations or hepatotoxicity). 17202432
Oertel WH, Benes H, Garcia-Borreguero D, Geisler P, Högl B, Saletu B, Trenkwalder C, et al; Rotigotine SP 709 Study Group. Efficacy of rotigotine transdermal system in severe restless legs syndrome: a randomized, double-blind, placebo-controlled, six-week dose-finding trial in Europe. Sleep Med 2008; 9: 228-39. (Among 341 patients with restless leg syndrome treated with rotigotine patches [5 doses] or placebo for 8 weeks, there were slight improvements in symptoms with rotigotine therapy, while side effects included application site reactions [37%], nausea, vomiting and dizziness; but “no clinically relevant changes” in clinical chemistry results were observed). 17553743
Hening WA, Allen RP, Ondo WG, Walters AS, Winkelman JW, Becker P, Bogan R, et al; SP792 Study Group. Rotigotine improves restless legs syndrome: a 6-month randomized, double-blind, placebo-controlled trial in the United States. Mov Disord 2010; 25: 1675-83. (Among 505 patients with restless leg syndrome treated with one of 4 doses of transdermal rotigotine or placebo for 6 months, symptom scores improved with higher doses [2 or 3 mg/24 hours] and side effects included application site reactions, nausea, somnolence, headache and insomnia, but there were no liver related serious adverse events). 20629075
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation, and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25,1425. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to an agent used to treat Parkinson disease). 23419359
Drugs for Parkinson's disease. Treat Guidel Med Lett 2013; 11 (135): 101-6. (Concise review of recommendations for therapy of Parkinson disease with description of mechanisms of action, efficacy and adverse events). 24165688
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an agent to treat Parkinson disease). 24552865
McAfee DA, Hadgraft J, Lane ME. Rotigotine: the first new chemical entity for transdermal drug delivery. Eur J Pharm Biopharm 2014; 88: 586-93. (Review of the development, pharmacokinetics, clinical efficacy of transdermal formulations of rotigotine mentions that the main adverse reactions are application site reactions, nausea and somnolence; no mention of serum enzyme elevations or hepatotoxicity). 25173087
Nomoto M, Mizuno Y, Kondo T, Hasegawa K, Murata M, Takeuchi M, Ikeda J, et al. Transdermal rotigotine in advanced Parkinson's disease: a randomized, double-blind, placebo-controlled trial. J Neurol 2014; 261: 1887-93. (Among 172 Japanese patients with advanced Parkinson disease treated with rotigotine [up to 16 mg/24 hours] or placebo for 14 weeks, symptoms improved more with rotigotine than placebo treatment and adverse events included application site reactions, nausea and somnolence; there were no liver related serious adverse events). 25022939
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury from the US enrolled in a prospective database between 2004 and 2012, none were attributed to an agent used to treat Parkinson disease). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Rotigotine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Rotigotine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Rotigotine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rotigotine)